# Elafibranor

## OVERVIEW

### Introduction

Elafibranor is an orally available peroxisome proliferator-activated receptor agonist that is used in combination with ursodeoxycholic acid to treat primary biliary cholangitis. Elafibranor therapy is associated with rare instances of worsening of liver enzymes during therapy but has not been convincingly linked to episodes of clinically apparent liver injury with jaundice.

### Background

Elafibranor (el’ a fib’ ran or) is an agonist of the peroxisome proliferator-activated receptors (PPAR) alpha (α), delta (δ), and gamma (γ), intracellular receptors with major effects on bile acid synthesis and transport as well as lipid metabolism and glucose homeostasis. Studies of other PPAR agonists such as pioglitazone and fenofibrate have suggested at least partial improvement in disease activity with their use in several liver diseases. Furthermore, the PPARα agonist bezafibrate has been shown to improve liver tests and histology in patients with primary biliary cholangitis (PBC, previously known as primary biliary cirrhosis) and is approved for use in Europe and Japan. Elafibranor has been shown to improve serum enzymes in several diseases including nonalcoholic steatohepatitis (NASH) and primary biliary cholangitis. In a large, placebo controlled trial in PBC, elafibranor therapy was associated with significant improvements in serum alkaline phosphatase levels in 51% of patients compared to only 4% of placebo recipients. Treatment did not improve symptoms, and liver biopsies were not done for assessment of histological changes. Based upon its effects on serum aminotransferase and alkaline phosphatase levels, elafibranor was granted accelerated approval in 2024 for treatment of adults with PBC who have an inadequate response to or intolerance of ursodeoxycholic acid (ursodiol). It is typically given in combination with ursodiol but can be given as monotherapy in patients who are intolerant to ursodiol. Elafibranor has not been shown to prolong survival or prevent progression to cirrhosis in patients with PBC, and its continued approval is contingent on further demonstration of its clinical benefit. Elafibranor is available as tablets of 80 mg under the brand name Iqirvo. The recommended dose is 80 mg once daily. Elafibranor is not recommended for patients with advanced or decompensated cirrhosis, or complete biliary obstruction. Common adverse events include weight gain, diarrhea, abdominal pain, nausea, vomiting, arthralgia, constipation, muscle injury, gastroesophageal reflux, dry mouth, weight loss, and rash. Uncommon but potentially severe adverse events include myopathy and rhabdomyolysis, bone fractures, hypersensitivity reactions, and embryo-fetal toxicity. The risk of myalgia and rhabdomyolysis may be increased by concurrent therapy with statins, and assessment for muscle symptoms and serum creatine phosphokinase (CPK) levels is recommended before and during therapy. Elafibranor may cause fetal harm if taken during pregnancy. Women of child-bearing potential should be tested for pregnancy before starting elafibranor and practice an effective means of birth control during therapy.

### Hepatotoxicity

In preregistration clinical trials, elafibranor was found to decrease both serum aminotransferase and alkaline phosphatase elevations in a high proportion of patients with PBC. In preliminary dose-finding studies in healthy volunteers, elevations of ALT and AST levels above 5 times the upper limit of normal (ULN) were found to be dose related and occurred in one-third of subjects exposed to doses above 120 mg daily. In contrast, in clinical trials of elafibranor in doses of 80 mg daily in patients with NASH and PBC, ALT elevations above 5 times ULN occurred in only 1% to 2% of patients, typically arising within the first few months of therapy and resolving spontaneously without drug interruption and without jaundice or symptoms. Careful assessment of cases with ALT elevations concluded that 3 were possibly due to drug induced injury, 2 among 138 patients with PBC and 1 among 1433 patients with NASH. Among patients with myalgia and CPK elevations during elafibranor therapy, one patient with preexisting cirrhosis who was also taking a statin, developed jaundice [5.5 mg/dL] with elevations in ALT [300 U/L] and AST [828 U/L] concurrent with rhabdomyolysis [CPK 12,647 U/L] and subsequently suffered hepatic decompensation. The incidence of gallstones and cholecystitis also may be increased with elafibranor therapy. Rare instances of drug induced liver injury are known to occur with other PPARα (fenofibrate, bezafibrate) and PPARγ (pioglitazone, rosiglitazone) agonists.

Likelihood score: E* (unproven but suspected rare cause of clinically apparent liver injury).

### Mechanism of Liver Injury

The mechanism by which elafibranor might cause liver injury is unclear, but clinically apparent liver injury from other fibrates is likely immune mediated. Elafibranor is metabolized in the liver by multiple CYP isoenzymes and is susceptible to drug-drug interactions.

### Outcome and Management

The product label for elafibranor has a warning about drug induced liver injury and recommends assessing symptoms, signs, and laboratory features of liver disease before starting therapy and monitoring thereafter, with interruption if liver tests worsen or signs and symptoms of acute liver injury arise. If liver tests improve upon stopping but recur with restarting elafibranor, therapy should be permanently discontinued. There is little or no information on cross sensitivity to liver injury or adverse events between elafibranor and other therapies for PBC such as ursodiol, obeticholic acid, and other fibrates.

Drug Class: Liver Disease Agents; Obeticholic Acid, Ursodiol

Other PPAR Agonists: Bezafibrate, Fenofibrate, Pioglitazone, Rosiglitazone

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Elafibranor – Iqirvo®

DRUG CLASS

Liver Disease Agents

COMPLETE LABELING (http://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Elafibranor)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Elafibranor | 923978-27-2 | C22-H24-O4-S
Bezafibrate | 41859-67-0 | C19-H20-ClNO4
Fenofibrate | 49562-28-9 | C20-H21-ClO4

## ANNOTATED SELECTED BIBLIOGRAPHY

References updated: 24 July 2024

Abbreviations: NAFLD, nonalcoholic fatty liver disease; NASH, nonalcoholic steatohepatitis; PBC, primary biliary cholangitis (cirrhosis); PPAR, peroxisome proliferator-activated receptor; PSC, primary sclerosing cholangitis.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of PPAR agonists).
Powers AC, D’Alessio D. Thiazolidinediones: Endocrine pancreas and pharmacotherapy of diabetes mellitus and hypoglycemia. In, Brunton LL, Halal R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 876-7. (Textbook of pharmacology and therapeutics, discusses PPAR-gamma agonists only).
FDA. 2024. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2024/218860Orig1s000IntegratedR.pdf (FDA website with product label and integrated clinical review of data on elafibranor provided by the sponsor in support of its approval as therapy of primary biliary cholangitis [PBC], mentions that serum aminotransferase elevations were common with high doses of elafibranor [above 120 mg daily] and were occasionally seen with recommended doses [1%-2%], but there were no episodes of definite drug induced liver injury in the preregistration trials).
Iwasaki S, Ohira H, Nishiguchi S, Zeniya M, Kaneko S, Onji M, Ishibashi H, et al.; Study Group of Intractable Liver Diseases for Research on a Specific Disease, Health Science Research Grant, Ministry of Health, Labour and Welfare of Japan. The efficacy of ursodeoxycholic acid and bezafibrate combination therapy for primary biliary cirrhosis: A prospective, multicenter study. Hepatol Res. 2008;38:557-64. (Study one: Among 45 patients with PBC treated with either bezafibrate or ursodiol, serum Alk P levels improved similarly in both groups and were within normal limits in 58% vs 38% by 24 weeks. Study two: Among 21 patients with PBC with an incomplete response to ursodiol, addition of bezafibrate led to further improvements in Alk P levels that were within normal limits in 60% by week 24 but remained elevated in all who did not have bezafibrate added; no mention of worsening liver tests, but 3 of 31 bezafibrate treated subjects developed CPK elevations). 18452482
Levy C, Peter JA, Nelson DR, Keach J, Petz J, Cabrera R, Clark V, et al. Pilot study: fenofibrate for patients with primary biliary cirrhosis and an incomplete response to ursodeoxycholic acid. Aliment Pharmacol Ther. 2011;33:235-42. (Among 20 patients with an incomplete response to ursodiol treated with addition of fenofibrate [160 mg/day] for 48 weeks, Alk P levels decreased [median 351 to 171 U/L] as did AST and IgM levels, while pruritus rates did not change and adverse events included heartburn [25%] and transient, early 2- to 5-fold increases in ALT and AST [10%] but no clinically apparent liver injury with jaundice). 21083674
Reig A, Sesé P, Parés A. Effects of bezafibrate on outcome and pruritus in primary biliary cholangitis with suboptimal ursodeoxycholic acid response. Am J Gastroenterol. 2018;113:49-55. (Among 48 patients with PBC with an incomplete response to ursodiol who had the addition of bezafibrate, alkaline phosphatase fell into the normal range in 26 [54%] who also had improvements in itching and subsequently suffered no serious clinical outcomes [liver decompensation, cancer, death or liver transplantation], while the 22 not achieving normal alkaline phosphatase levels had less improvement in itching and 5 instances of serious clinical outcomes). 29016567
Corpechot C, Chazouillères O, Rousseau A, Le Gruyer A, Habersetzer F, Mathurin P, Goria O, et al. A placebo-controlled trial of bezafibrate in primary biliary cholangitis. N Engl J Med. 2018;378:2171-2181. (Among 100 patients with PBC and an incomplete response to ursodiol treated with bezafibrate or placebo for 24 months, Alk P levels fell into the normal range in 67% vs 2% and symptoms improved slightly, while adverse event rates were similar (49% vs 51%), including serious adverse events (28% vs 24%) and ALT elevations rising to 5 times ULN occurred in 6% vs 2%; 2 patients on bezafibrate having liver biopsy appearance of autoimmune hepatitis discontinued therapy and were treated successfully with corticosteroids). 29874528
Honda A, Tanaka A, Kaneko T, Komori A, Abe M, Inao M, Namisaki T, et al.; Japan PBC Study Group. Bezafibrate improves GLOBE and UK-PBC scores and long-term outcomes in patients with primary biliary cholangitis. Hepatology. 2019;70:2035-2046. (Among 118 Japanese patients with PBC treated with ursodiol for at least a year followed by its combination with bezafibrate for a year, there was no decrease in risk of clinical outcomes but there were changes in risk scores that predicted fewer outcome in the future). 30737815
Lleo A, Wang GQ, Gershwin ME, Hirschfield GM. Primary biliary cholangitis. Lancet. 2020;396(10266):1915-1926. (Review of the clinical features, diagnosis, natural history, etiology, and therapy of PBC; no mention of hepatoxicity of medications used in treatment). 33308474
de Vries E, Bolier R, Goet J, Parés A, Verbeek J, de Vree M, Drenth J, et al.; Netherlands Association for the Study of the Liver-Cholestasis Working Group. Fibrates for itch (FITCH) in fibrosing cholangiopathies: a double-blind, randomized, placebo-controlled trial. Gastroenterology. 2021;160:734-743.e6. (Among 74 patients with moderate-to-severe pruritus due to chronic cholestatic liver disease treated with bezafibrate or placebo for 21 days, serum alkaline phosphatase levels and pruritus decreased with bezafibrate but not placebo and there were no serious adverse events or episodes of worsening of serum liver enzymes). 33031833
Sorda JA, González Ballerga E, Barreyro FJ, Avagnina A, Carballo P, Paes de Lima A, et al. Bezafibrate therapy in primary biliary cholangitis refractory to ursodeoxycholic acid: a longitudinal study of paired liver biopsies at 5 years of follow up. Aliment Pharmacol Ther. 2021;54:1202-1212. (Among 49 patients with PBC and an incomplete response to ursodiol who were treated with addition of bezafibrate, serum Alk P levels fell into the normal range in 86% by 1 year and repeat liver biopsies in 31 patients at 5 years showed a decrease in fibrosis in 48% and decline in cirrhosis rate from 19% to 3%). 34587309
Ratziu V, Harrison SA, Francque S, Bedossa P, Lehert P, Serfaty L, Romero-Gomez M, et al.; GOLDEN-505 Investigator Study Group. Elafibranor, an agonist of the peroxisome proliferator-activated receptor-α and -δ, induces resolution of nonalcoholic steatohepatitis without fibrosis worsening. Gastroenterology. 2016;150:1147-1159.e5. (Among 276 patients with nonalcoholic steatohepatitis [NASH] without cirrhosis treated with elafibranor [80 and 120 mg] or placebo once daily for 52 weeks, there were no differences in rates of NASH resolution in the 3 groups although serum alkaline phosphatase and GGT levels decreased more on elafibranor, while rates of adverse events were similar in the 3 groups, those on elafibranor were more likely to have nausea, vomiting, diarrhea, renal impairment, myalgia, decreased appetite, and rash; no mention of worsening of ALT or hepatotoxicity). 26874076
Schattenberg JM, Pares A, Kowdley KV, Heneghan MA, Caldwell S, Pratt D, Bonder A, et al. A randomized placebo- controlled trial of elafibranor in patients with primary biliary cholangitis and incomplete response to UDCA. J Hepatol. 2021;74:1344-1354. (Among 45 patients with PBC and an incomplete response to ursodiol treated with elafibranor [80 or 120 mg] or placebo once daily for 12 weeks, serum levels of alkaline phosphatase and GGT decreased with elafibranor but not placebo therapy, while there was little change in symptoms or ALT levels and adverse event rates were similar in all 3 groups although 2 patients receiving elafibranor developed elevations in ALT, both of whom stopped therapy, one received corticosteroids). 33484775
Kamata S, Honda A, Ishikawa R, Akahane M, Fujita A, Kaneko C, Miyawaki S, et al. Functional and structural insights into the human PPARα/δ/γ targeting preferences of anti-NASH investigational drugs, lanifibranor, seladelpar, and elafibranor. Antioxidants (Basel). 2023;12:1523. (Functional assays for PPARα, δ, and γ binding and activity demonstrate that elafibranor binds to and activates all three subtypes of PPAR, inducing antioxidant genes, as well as mediators of pathways of lipid and glucose metabolism and inflammation). 37627519
Jorge Nardelli M, Rodrigues Maffia L, Alves Gelape F, Grossi Lopes Cançado G, Alves Couto C. Bezafibrate severe late onset drug-induced liver injury in primary biliary cholangitis: case report. J Gastrointestin Liver Dis. 2023;32:413-414. (65 year old woman developed AMA negative PBC with little response to ursodiol and a transient partial response to bezafibrate, eventually with progressive jaundice and death from liver failure interpreted as drug induced liver injury but with latency of several years, no dechallenge on stopping, and course compatible with progressive PBC and lack of sustained response to bezafibrate). 37774223
Cheung AC, Lapointe-Shaw L, Kowgier M, Meza-Cardona J, Hirschfield GM, Janssen HL, Feld JJ. Combined ursodeoxycholic acid (UDCA) and fenofibrate in primary biliary cholangitis patients with incomplete UDCA response may improve outcomes. Aliment Pharmacol Ther. 2016;43:283-93. (In a retrospective analysis, comparison of patients with PBC treated with ursodiol alone [n=66] or combined with fenofibrate [n=66: cohorts matched for age, cirrhosis, Alk P, bilirubin and platelet counts] for a median of 11 months demonstrated greater decreases in Alk P levels and improved decompensation- and transplant-free survival with fenofibrate, but 1 patient developed ALT elevations above 5 times ULN after 5.4 years which resolved upon stopping). 26559762
Hegade VS, Khanna A, Walker LJ, Wong LL, Dyson JK, Jones DEJ. Long-term fenofibrate treatment in primary biliary cholangitis improves biochemistry but not the UK-PBC risk score. Dig Dis Sci. 2016;61:3037-3044. (Among 23 patients with PBC and an incomplete response to ursodiol who were treated with the addition of fenofibrate [200 mg daily] for a median of 21 months, there were sustained improvements in Alk P levels, but no improvement in the UK-PBC risk scores for decreasing liver-related deaths or liver transplantations). 27435324
Ghonem NS, Auclair AM, Hemme CL, Gallucci GM, de la Rosa Rodriguez R, Boyer JL, Assis DN. Fenofibrate improves liver function and reduces the toxicity of the bile acid pool in patients with primary biliary cholangitis and primary sclerosing cholangitis who are partial responders to ursodiol. Clin Pharmacol Ther. 2020;108:1213-1223. (In a retrospective analysis of 31 patients with PBC or PSC with an incomplete response to ursodiol therapy who had the addition of fenofibrate [160 mg daily], alkaline phosphatase levels fell into the normal range in 84% and total serum bile acid levels improved as well). 32480421
Liu Y, Guo G, Zheng L, Sun R, Wang X, Deng J, Jia G, et al. Effectiveness of fenofibrate in treatment-naive patients with primary biliary cholangitis: a randomized clinical trial. Am J Gastroenterol. 2023;118:1973-1979. (Among 117 Chinese patients with newly diagnosed PBC treated with ursodiol alone vs urso and fenofibrate [200 mg daily] for 12 months, Alk P fell into the normal range in 40% vs 62% by 12 months, while ALT elevations arose in 8% vs 19%, none were above 5 times ULN and all resolved spontaneously). 36892506
Tanaka A, Corpechot C. PPAR agonists in PBC: where do we go from here? or how to choose between the new and the old. Clin Res Hepatol Gastroenterol. 2024;48:102358. (Review of recent phase 3 trials of seladelpar and elafibranor [PPAR agonists] demonstrating achievement of endpoint of improvements in serum alkaline phosphatase but not a decrease in long term complications of PBC, whereas the many trials of bezafibrate with long term follow up have shown improvements in alkaline phosphatase levels and also liver histology, fibrosis, and in mortality and need for liver transplantation). 38677506
Kowdley KV, Bowlus CL, Levy C, Akarca US, Alvares-da-Silva MR, Andreone P, Arrese M, et al; ELATIVE Study Investigators’ Group; ELATIVE Study Investigators' Group. Efficacy and safety of elafibranor in primary biliary cholangitis. N Engl J Med. 2024;390:795-805. (Among 161 patients with PBC and an incomplete response to ursodiol treated with elafibranor [80 mg] or placebo for 52 weeks, improvements in alkaline phosphatase to less than 167 U/L occurred in 51% of those on elafibranor vs 4% on placebo, and while total [96% vs 91%] and serious adverse event rates [11% vs 11%] were similar in the 2 groups, those on elafibranor were more likely to have abdominal pain [11% vs 6%], diarrhea [11% vs 9%], nausea [11% vs 6%] and vomiting [11% vs 2%], and 1 patient on elafibranor developed possible and 2 on placebo developed probable drug induced liver injury). 37962077

## OTHER REFERENCE LINKS

1. Recent References on Elafibranor: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Elafibranor/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Elafibranor: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Elafibranor)